# Naldemedine

## OVERVIEW

### Introduction

Naldemedine is a peripherally acting opioid antagonist which is used to treat constipation caused by chronic opioid use. Naldemedine has not been linked to serum enzyme elevations during therapy or to clinically apparent liver injury.

### Background

Naldemedine (nal dem' e deen) is a semisynthetic opiate receptor antagonist which is similar structurally to naltrexone and blocks mu receptors in the enteric nervous system of the gastrointestinal tract resulting in an inhibition of opioid induced slowing of peristalsis. Naldemedine has a large polar side chain that does not block its engagement with opioid receptors, but does prevent it from crossing the blood brain barrier. As a consequence, naldemedine reverses the peripheral but not the central nervous system effects of opiates, such as pain relief and euphoria. In large preregistration trials, naldemedine was found to increase spontaneous bowel movement frequency and reduce constipation related side effects of opiates used for analgesia in patients with chronic, non-cancer pain. Naldemedine was approved for this use in the United States in 2017 and is currently available as tablets of 0.2 mg under the brand name Symproic. The recommended dose regimen is 0.2 mg once daily. Side effects can include abdominal pain, diarrhea, nausea, flatulence, anxiety, restlessness and sweating. Rare but potentially severe adverse events include withdrawal symptoms, hypersensitivity reactions and gastrointestinal perforation. Naldemedine has minimal effects on constipation in persons not taking opioids.

### Hepatotoxicity

Therapy with naldemedine has not been linked to serum enzyme elevations or to clinically apparent liver injury. In preregistration studies, liver test abnormalities arose in less than 1% of treated patients but were transient, mild and not associated with symptoms. There were no reported cases of liver injury with jaundice or symptoms. Since its approval and more widescale use, there have been no published reports of hepatotoxicity attributed to naldemedine.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which naldemedine might cause liver injury is not known. Naldemedine is extensively metabolized in the liver, largely by CYP 3A4 and is a substrate for P-glycoprotein. It is susceptible to drug-drug interactions with agents that induce or inhibition CYP 3A or P-glycoprotein activity. Most opioid antagonists appear to have little intrinsic hepatotoxicity. The absence of evidence of hepatotoxicity for naldemedine may be in part due to the low total daily dose (<1 mg).

Drug Classes: Gastrointestinal Agents, Cathartics and Laxatives; Opioid Antagonists; Substance Abuse Treatment Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Naldemedine – Symproic®

DRUG CLASS

Gastrointestinal Agents; Opioid Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Naldemedine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Naldemedine | 916072-89-4 | C32-H34-N4-O6 | Naldemedine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 15 April 2019

Zimmerman HJ. Narcotic analgesics. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 710-11. (Expert review of hepatotoxicity published in 1999; mentions that trials of naltrexone have reported serum aminotransferase elevations in up to 30% of recipients, an effect that appeared to be partially dose dependent; naldemedine not discussed).
Larrey D, Ripault MP. Illegal and recreational compounds. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 456-7. (Review of hepatotoxicity discusses buprenorphine, an orally available morphine analogue, which has been linked to cases of severe acute liver injury, usually as a result of intravenous administration; naldemedine is not discussed).
Yaksh TL, Wallace MS. Opioids, analgesia, and pain management. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 355-86. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2017/208854Orig1s000MedR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; rates of liver test abnormalities were similar with naldemedine [0.8%: 9 of 1163] as placebo [0.8%: 9 of 1165] and no convincing case of clinically apparent liver injury could be attributed to naldemedine).
Webster LR, Yamada T, Arjona Ferreira JC. A phase 2b, randomized, double-blind placebo-controlled study to evaluate the efficacy and safety of naldemedine for the treatment of opioid-induced constipation in patients with chronic noncancer pain. Pain Med 2017; 18: 2350-60. (Among 244 patients with non-cancer pain and opioid induced constipation, naldemedine [0.1,0.2 or 0.4 mg] was associated with a higher, dose dependent response rate, while changes in chemistry laboratory results from baseline “were similar for all treatment groups”). 28371937
Hale M, Wild J, Reddy J, Yamada T, Arjona Ferreira JC. Naldemedine versus placebo for opioid-induced constipation (COMPOSE-1 and COMPOSE-2): two multicentre, phase 3, double-blind, randomised, parallel-group trials. Lancet Gastroenterol Hepatol 2017; 2: 555-64. (Among 1100 patients with opioid induced constipation enrolled in 2 placebo controlled 12 week trials, response rates were higher with naldemedine than placebo while adverse event rates were similar [22% vs 17%], diarrhea, nausea and abdominal pain being more frequent with naldemedine; no mention of ALT elevations or hepatotoxicity). 28576452
Katakami N, Oda K, Tauchi K, Nakata K, Shinozaki K, Yokota T, Suzuki Y, et al. Phase IIb, randomized, double-blind, placebo-controlled study of naldemedine for the treatment of opioid-induced constipation in patients with cancer. J Clin Oncol 2017; 35: 1921-8. (Among 227 patients with cancer and opioid induced constipation treated with naldemedine [0.1,0.2 or 0.4 mg] or placebo once daily for 14 days, response rates were higher with naldemedine and were dose related as were adverse event rates, diarrhea arising in 27%, 40% and 52% vs 25% in controls; no mention of ALT elevations or hepatotoxicity). 28445097
Katakami N, Harada T, Murata T, Shinozaki K, Tsutsumi M, Yokota T, Arai M, et al. Randomized phase III and extension studies of naldemedine in patients with opioid-induced constipation and cancer. J Clin Oncol 2017; 35: 3859-66. (Among 193 patients with cancer and opioid induced constipation treated with naldemedine or placebo for 2 weeks followed by naldemedine for 12 weeks, clinical responses were more frequent with naldemedine [71% vs 34%] as were adverse events [44% vs 26%], and one developed a severe adverse event described as “abnormal hepatic function” but no details given). 28968171
Markham A. Naldemedine: first global approval. Drugs 2017; 77: 923-7. (Summary of the structure, mechanism of action, pharmacology, clinical efficacy and safety of naldemedine; mentions that the most common adverse events are diarrhea, abdominal pain and nausea; no mention of ALT elevations or hepatotoxicity). 28466424
Naldemedine (Symproic) for opioid-induced constipation. Med Lett Drugs Ther 2017; 9 (1535): 196-8. (Concise review of the mechanism of action, clinical efficacy, safety and costs of naldemedine shortly after its approval in the US for opioid induced constipation; mentions adverse events of abdominal pain, nausea and diarrhea as well as hypersensitivity reactions, withdrawal symptoms and gastrointestinal perforation, but does not mention ALT elevations or hepatotoxicity). 29186083
Webster LR, Nalamachu S, Morlion B, Reddy J, Baba Y, Yamada T, Arjona Ferreira JC. Long-term use of naldemedine in the treatment of opioid-induced constipation in patients with chronic noncancer pain: a randomized, double-blind, placebo-controlled phase 3 study. Pain 2018; 159: 987-94. (Among 1246 patients with non-cancer pain and opioid induced constipation, overall adverse event rates were similar with naldemedine- [68%] as placebo-treatment [72%], while diarrhea was more frequent [11% vs 5%]; no mention of ALT elevations or hepatotoxicity). 29419653

## OTHER REFERENCE LINKS

1. Recent References on Naldemedine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Naldemedine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Naldemedine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Naldemedine)